# Diphenoxylate

## OVERVIEW

### Introduction

Diphenoxylate is synthetic opioid that primarily affects opiate receptors in the intestine and is used to treat diarrhea. Diphenoxylate has not been linked to serum enzyme elevations during therapy or to clinically apparent liver injury.

### Background

Diphenoxylate (dye” fen ox’ i late) is a synthetic piperidine derivative that acts as a mild opiate receptor agonist (predominant µ type receptors), but is used largely for the treatment of diarrhea rather than pain. Diphenoxylate is similar to loperamide and is not structurally related to morphine or codeine, and has minimal euphoric or analgesic effects, largely because it is given in low doses and in fixed combination with atropine. Diphenoxylate acts as a potent opiate agonist in the intestine and reduces intestinal motility, causing a slowing of intestinal transport and increased resorption of water and electrolytes, actions that are helpful in treating diarrhea. Typically, low doses of atropine are added to diphenoxylate to prevent abuse and excessive intake. Diphenoxylate in combination with atropine was approved for use in the United States in 1960 and is still widely used to treat acute infectious and nonspecific diarrhea caused by gastroenteritis. Diphenoxylate with atropine is available as tablets 2.5 mg of diphenoxylate with 0.025 mg of atropine and as a solution of similar concentration in 5 mL generically and under the brand name Lomotil. The usual dose in adults is 5 mg four times a day for until diarrhea is controlled, followed by 2.5 mg up to four times daily as needed. Chronic therapy is not recommended. Side effects of diphenoxylate include abdominal bloating and pain, nausea and vomiting and constipation. Because there is systemic absorption, diphenoxylate can also cause central nervous system opioid effects such as confusion, drowsiness, euphoria, dizziness, headache, and respiratory depression. Rare side effects include hypersensitivity reactions, pancreatitis and paralytic ileus. Diphenoxylate with atropine is classified as a controlled substance schedule V, indicating that it has a minimal potential for abuse. Diphenoxylate is available by prescription only.

### Hepatotoxicity

As with most opiates in current use, therapy with diphenoxylate with atropine has not been linked to serum enzyme elevations. There have been no convincing cases of idiosyncratic acute, clinically apparent liver injury attributed to diphenoxylate. The reason for its lack of hepatotoxicity may relate partially to the low doses used. What diphenoxylate that is absorbed is metabolized in the liver.

References on the safety and potential hepatotoxicity of diphenoxylate are given in the Overview section of the Opioids.

Drug Class: Gastrointestinal Agents; Opioids

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Diphenoxylate (with Atropine) – Generic, Lomotil®

DRUG CLASS

Gastrointestinal Agents; Opioids

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Diphenoxylate)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Diphenoxylate | 915-30-0 | C30-H32-N2-O2 | Diphenoxylate Chemical Structure

## OTHER REFERENCE LINKS

1. Recent References on Diphenoxylate: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Diphenoxylate+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Diphenoxylate: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Diphenoxylate)